# Octreotide

## OVERVIEW

### Introduction

Octreotide is a synthetic somatostatin analogue that resembles the native polypeptide in its activity in suppressing levels and activity of growth hormone, insulin, glucagon and many other gastrointestinal peptides. Because its half-life is longer than somatostatin, octreotide can be used clinically to treat neuroendocrine tumors that secrete excessive amounts of growth hormone (acromegaly) or other active hormones or neuropeptides. Octreotide has many side effects including suppression of gall bladder contractility and bile production, and maintenance therapy can cause cholelithiasis, pancreatitis as well as clinically apparent liver injury.

### Background

Octreotide (ok tree' oh tide) is a synthetic cyclic octapeptide and analogue of somatostatin that is used for its ability to suppress levels and activities of other hormones (growth hormone, insulin, gastrin, secretin, glucagon) or active neuropeptides (serotonin, vasoactive intestinal polypeptide [VIP]). Natural somatostatin is produced in the hypothalamus and acts to suppress growth hormone release from the pituitary. Somatostatin is also found in other neurons throughout the body and particularly in intestinal and pancreatic neurons, where it is active in suppressing release of other hormones and neuropeptides such as insulin, glucagon, gastrin, secretin, motilin, VIP, serotonin and cholecystokinin. Octreotide has a longer half-life (1 to 2 hours) than somatostatin (~3 minutes) and yields effective suppression of hormone production when given three times daily. More recently, longer acting formulations of octreotide have been developed that can be administered weekly or monthly. Octreotide appears to interact largely with the somatostatin subtype 2 and possibly subtype 5 receptors, with little effect on subtypes 1, 3 and 4, explaining its focused effects. Octreotide therapy has been shown to improve symptoms and complications of several neuroendocrine tumors including abnormal growth in acromegaly due to growth hormone secreting pituitary tumors, diarrhea due to VIP secreting intestinal tumors and flushing due to carcinoid tumors. Octreotide was approved for use in the United States in 1988 and current listed indications include acromegaly, watery diarrhea from VIP producing tumors and diarrhea and flushing due to metastatic carcinoid tumors. Octreotide has been used off-label for portal hypertension to control variceal hemorrhage as well as for dumping syndrome and other gastrointestinal motility disorders. Octreotide is available generically and under the brand name Sandostatin in several forms for intravenous or subcutaneous administration. A long acting form is available that can be given monthly (Sandostatin LAR Depot). The typical dose in adults is 100 mcg given as injections three times daily in 2 weeks courses, and then for long term maintenace as injections 2 to 4 times daily or less frequently with long acting formulations. Side effects are common. Adverse events from single injections include influenza-like symptoms of fatigue, headache, nausea and vomiting and local infusion reactions. With continued therapy, adverse events can include diarrhea, abdominal pain, back pain, headache, dizziness, hypothyroidism, hypo- and hyperglycemia, arrhythmias and gall bladder disease.

### Hepatotoxicity

Mild, transient, asymptomatic elevations in serum aminotransferase levels occur in a small proportion of patients receiving octreotide, and in some individuals the elevations are persistent and worsen over time and may require drug discontinuation. In addition, several instances of acute, clinically apparent liver injury attributable to octreotide have been described. The onset is generally within 1 to 6 months of starting therapy and injury may be more frequent with higher doses. Most cases of liver injury associated with octreotide therapy have been asymptomatic and anicteric, and marked by prominent elevations in serum ALT and AST with normal or near normal serum alkaline phosphatase, GGT and bilirubin. In some instances, however, jaundice has arisen, particularly with rechallenge. There have been no instances of acute liver failure or vanishing bile duct syndrome associated with octreotide, and a characteristic feature of the injury is the rapidity of improvement upon stopping the injections or infusions. Several instances of marked aminotransferase elevations with rapid improvements on stopping have been reported in newborns and infants with congenital hyperinsulinemia who were treated with continuous infusions of high doses of octreotide.

Octreotide causes inhibition of gall bladder contractility and decrease in bile secretion, and long term therapy is associated with a high rate of cholesterol gallstone formation. In prospective studies, between 25% and 65% of patients with acromegaly treated with maintenance octreotide developed gallstones detected by ultrasonography and a proportion developed symptomatic cholelithiasis requiring hospitalization and cholecystectomy. Even after cholecystectomy, cholesterol stones may form in the common bile duct and intrahepatic ducts causing symptoms, episodes of sepsis and need for partial hepatic resection. Therapy with ursodiol does not appear to prevent gallstone formation during octreotide therapy, although it may help. Octreotide has also been associated with acute pancreatitis, which may be due to its inhibitory effect on gastrointestinal hormone release, although other cases may be secondary to passage of gall bladder stones and pancreatic duct obstruction.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

Octreotide, like somatostatin, decreases cholecystokinin secretion, gall bladder contractility and bile secretion, perhaps accounting for the high rate of gall bladder sludge and stone formation with long term use. How infusions of octreotide cause acute liver injury independent of its effect on bile flow and gall bladder function is uncertain. Octreotide is a polypeptide and, as such, should not have direct or even indirect hepatic toxicity. Thus, the liver injury, like the gall bladder effects, is likely caused by what octreotide does, rather than by its chemical structure or what it is. Octreotide has multiple effects on gastrointestinal motility and changes bowel transient, bacterial composition in the intestines and bile acid levels. In addition, glycogenosis caused by changes in insulin and glucagon is a possible cause of the serum ALT and AST elevations that occur with high doses of octreotide and would account for the rapidity of improvement upon stopping.

### Outcome and Management

The liver injury due to the octreotide generally resolves rapidly with stopping therapy. It also usually recurs upon restarting and may be more severe. For these reasons, patients that are restarted on treatment after an episode of liver injury should be monitored carefully for possible recurrence.

Drug Class: Hormonal Agents; Antineoplastic Agents, Peptide Hormones; Gastrointestinal Agents, Antidiarrheals

Other Drugs in the Subclass, Hormonal Agents, Somatostatin Analogues: Lanreotide, Pasireotide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Octreotide – Generic, Sandostatin®

DRUG CLASS

Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Octreotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lanreotide | 108736-35-2 | C54-H69-N11-O10-S2
Octreotide | 83150-76-9 | C49-H66-N10-O10-S2 | Octreotide structure
Pasireotide | 396091-73-9 | C58-H66-N10-O9
Somatostatin | 51110-01-1 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 March 2016

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity published in 1999, mentions that octreotide has been implicated in several cases of acute hepatocellular injury which subsided after drug withdrawal).
Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd edition. Amsterdam: Elsevier, 2013. (Multiauthored text book on drug induced liver injury; does not discuss octreotide).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-49. (Textbook of pharmacology and therapeutics).
Kvols LK, Moertel CG, O'Connell MJ, Schutt AJ, Rubin J, Hahn RG. Treatment of the malignant carcinoid syndrome. Evaluation of a long-acting somatostatin analogue. N Engl J Med 1986; 315: 663-6. (Among 25 patients with metastatic carcinoid tumors treated with octreotide for 2 to 18 months, tolerance was “excellent” and “no evidence of …hepatic... toxicity was found”). 2427948
Arosio M, Bazzoni N, Ambrosi B, Faglia G. Acute hepatitis after treatment of acromegaly with octreotide. Lancet 1988; 2 (8626-8627): 1498. (50 year old man with acromegaly developed abnormal liver tests without symptoms 5 months after starting octreotide [ALT 143 U/L, Alk P 1269 U/L, bilirubin not given], which resolved within 3 weeks of stopping and arose again with jaundice 3 months after restarting [bilirubin 12.8 mg/dL, ALT 2140 U/L, Alk P 1324 U/L], resolving again within 2 months of stopping). 2904619
Ho KY, Weissberger AJ, Marbach P, Lazarus L. Therapeutic efficacy of the somatostatin analog SMS 201-995 (octreotide) in acromegaly. Effects of dose and frequency and long-term safety. Ann Intern Med 1990; 112: 173-81. (Among 18 patients with acromegaly treated with octreotide for at least one year, 9 [50%] developed gallstones, which were “small and numerous” and 2 [11%] developed symptoms and underwent cholecystectomy). 2404445
Daughaday WH. Octreotide is effective in acromegaly but often results in cholelithiasis. Ann Intern Med 1990; 112: 159-60. (Editorial in response to Ho [1990] on the safety of octreotide in acromegaly recommends that it be limited to cases refractory to surgery). 2404444
Minocha A, Dean HA Jr. Octreotide-induced acute hepatic toxicity. Am J Gastroenterol 1991; 86: 525. (53 year old man with cirrhosis and variceal hemorrhage developed serum enzyme elevations within 12 hours of starting infusions of octreotide [bilirubin levels not given, ALT rising from 59 to 1190 U/L, Alk P 81-151 U/L], enzymes decreasing rapidly upon stopping). 2012056
Catnach SM, Anderson JV, Fairclough PD, Trembath RC, Wilson PA, Parker E, Besser GM, Wass JA. Effect of octreotide on gall stone prevalence and gall bladder motility in acromegaly. Gut 1993; 34: 270-3. (Gallstones were found by ultrasound in 34% of 39 acromegalic patients who had received octreotide vs 16% of 38 patients who had not). 8432484
Hussaini SH, Pereira SP, Murphy GM, Kennedy C, Wass JA, Besser GM, Dowling RH. Composition of gall bladder stones associated with octreotide: response to oral ursodeoxycholic acid. Gut 1995; 36: 126-32. (Among 14 patients with acromegaly who were treated with octreotide and had gall bladder stones, chemical analysis in 2 showed cholesterol-rich stones; gall bladder bile in 6 was supersaturated with cholesterol; and ursodiol therapy resulted in partial or complete stone dissolution in 5 of 9 subjects).
González-Martín JA, Donnay S, Morillas J, Gómez-Aparicio C, Garcia-Cano J, Pérez-Vigara G, Roldán A. Acute liver injury and octreotide. Am J Gastroenterol 1996; 91: 2434-5. (54 year old woman with acromegaly developed marked ALT elevations within a day of starting octreotide [ALT 538 U/L, GGT 133 U/L, bilirubin normal], which resolved within 2 weeks of stopping and recurred on rechallenge with a single dose [ALT 673 U/L]). 8931436
Radetti G, Gentili L, Paganini C, Messner H. Cholelithiasis in a newborn following treatment with the somatostatin analogue octreotide. Eur J Pediatr 2000; 159: 550. (Newborn with congenital hyperinsulinemia developed jaundice 5 weeks after starting octreotide [bilirubin direct 3.6 and total 3.9 mg/dL, ALT 152 U/L, GGT 187 U/L], ultrasound showed stones in gall bladder and common duct, and abnormalities resolved within 6 weeks of lowering the octreotide dose and starting ursodiol). 10923237
Sheehan MT, Nippoldt TB. Hepatolithiasis (intrahepatic stone) during octreotide therapy for acromegaly: a case report. Pituitary 2000; 3: 227-30. (27 year old man with acromegaly developed symptomatic cholelithiasis 5 years after starting octreotide and 2 years after cholecystectomyand presented later with recurrent painful intrahepatic stone disease [bilirubin 4.1 mg/dL, ALT 614 U/L, Alk P 192 U/L], ultimately requiring surgery). 11788010
Crook MA, Steger A. Abnormal liver function tests in a patient fed with total parenteral nutrition and treated with octreotide. Nutrition 2001; 17: 152-4. (54 year old woman with complications after cholecystectomy developed modest rises in liver tests on octreotide which worsened on parenteral nutrition [peak bilirubin 2.1 mg/dL, ALT 183 U/L, Alk P 199 U/L], resolving completely only when both were stopped). 11240342
Thomas LA, Veysey MJ, Murphy GM, Russell-Jones D, French GL, Wass JA, Dowling RH. Octreotide induced prolongation of colonic transit increases faecal anaerobic bacteria, bile acid metabolising enzymes, and serum deoxycholic acid in patients with acromegaly. Gut 2005; 54: 630-5. (Octreotide caused increases in colonic transit times which affected deoxycholic acid levels in stool and serum, changes which might result in an increased risk for gallstones). 15831907
Feenstra J, van Aken MO, de Herder WW, Feelders RA, van der Lely AJ. Drug-induced hepatitis in an acromegalic patient during combined treatment with pegvisomant and octreotide long-acting repeatable attributed to the use of pegvisomant. Eur J Endocrinol 2006; 154: 805-6. (45 year old man with acromegaly developed abnormal liver tests 5 months after pegvisomant [growth hormone receptor antagonist] was added to octreotide therapy [ALT 1148 U/L, Alk P 149 U/L, bilirubin not given], which decreased when pegvisomant was stopped and recurred when it was restarted alone without octreotide). 16728538
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to octreotide). 20949552
Avatapalle B, Padidela R, Randell T, Banerjee I. Drug-induced hepatitis following use of octreotide for long-term treatment of congenital hyperinsulinism. BMJ Case Rep 2012; 2012. (Baby girl with refractory congenital hyperinsulinemia developed rising ALT on high doses of octreotide [peak ALT 1061 U/L with normal Alk P and bilirubin], with “normal” liver biopsy and rapid resolution on stopping octreotide). 22850563
Ben-Ari J, Greenberg M, Nemet D, Edelstein E, Eliakim A. Octreotide-induced hepatitis in a child with persistent hyperinsulinemia hypoglycemia of infancy. J Pediatr Endocrinol Metab 2013; 26: 179-82. (8 month old boy with congenital hyperinsulinemia developed liver test abnormalities on high doses of octreotide [ALT 535 U/L, AST 1065 U/L, with normal Alk P and bilirubin], liver biopsy showing portal inflammation and “hydropic degeneration”, resolving within 4 days of stopping). 23327813
Koren I, Riskin A, Barthlen W, Gillis D. Hepatitis in an infant treated with octreotide for congenital hyperinsulinism. J Pediatr Endocrinol Metab 2013; 26: 183-5. (9 month old girl with congenital hyperinsulinemia developed abnormal liver tests 4 months after starting high doses of octreotide [peak ALT >1000 U/L with minimal increases in Alk P and GGT and normal bilirubin], falling to normal within 1 month of stopping). 23327817
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18] and nitrofurantoin [n=17]; no case was attributed to octreotide). 23419359
Levy-Khademi F, Irina S, Avnon-Ziv C, Levmore-Tamir M, Leder O. Octreotide-associated cholestasis and hepatitis in an infant with congenital hyperinsulinism. J Pediatr Endocrinol Metab 2015; 28: 449-51. (3 month of boy with congenital hyperinsulinemia had fluctuating liver test abnormalities on octreotide therapy [bilirubin rising to 20.1 mg/dL, direct 17 mg/dL, ALT 538 U/L, Alk P normal] and rapid recovery upon stopping). 25324442
Visentin M, Stieger B, Merz M, Kullak-Ublick GA. Octreotide inhibits the bilirubin carriers organic anion transporting polypeptides 1B1 and 1B3 and the multidrug resistance-associated protein 2. J Pharmacol Exp Ther 2015; 355: 145-51. (Studies using cell lines and membrane vesicles showed that octreotide inhibited several membrane transport proteins which are involved in bilirubin uptake and secretion). 26330539
Melmed S, Popovic V, Bidlingmaier M, Mercado M, van der Lely AJ, Biermasz N, Bolanowski M, et al. Safety and efficacy of oral octreotide in acromegaly: results of a multicenter phase III trial. J Clin Endocrinol Metab 2015; 100: 1699-708. (Among 155 patients with acromegaly switched from injectable therapy to oral octreotide, the majority had a durable beneficial effect and side effects were those typical of octreotide, 18 [12%] had a “hepatobiliary” disorder and 12 [8%] developed gallstones; while “clinically meaningful alterations were not observed in laboratory safety parameters”, although 2 patients are described who developed ALT elevations and jaundice). 25664604
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was judged probably due to octreotide, a 67 year old woman with severe heart disease, diabetes and gastrointestinal bleeding developed marked cholestasis [peak bilirubin 49.3 mg/dL, ALT 533 U/L, Alk P 1482 U/L] while in the intensive care unit receiving octreotide and multiple other medications). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Octreotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Octreotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Octreotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Octreotide)